# Trimethoprim-Sulfamethoxazole

## OVERVIEW

### Introduction

Sulfamethoxazole with trimethoprim is an oral, fixed dose combination of antibiotics that is widely used in short term courses for mild-to-moderate bacterial infections and chronically as prophylaxis against opportunistic infections. Like other sulfonamide-containing medications, this combination is a well-known, although rare cause of clinically apparent acute liver injury which can be severe and even fatal.

### Background

Trimethoprim-sulfamethoxazole (TMP-SMZ) is an oral, fixed dose combination of two antibiotics, a sulfonamide and a methoprim. This combination is widely used as therapy of acute infections due to susceptible bacteria as well as chronically for prevention of opportunistic infections with Pneumocystis jirovecii (formerly carinii) in immune deficient individuals. The two agents are synergistic in inhibition of folate synthesis – the sulfamethoxazole (sul" fa meth ox' a zole) inhibiting production of dihydrofolate from para-aminobenzoic acid, and the trimethoprim (trye meth' oh prim) inhibiting the next step in the pathway from dihydrofolate to tetrahydrofolate. TMP-SMZ was approved for use as a combination antibiotic in the United States in 1973 and is still in wide use, more than 4 million prescriptions being filled yearly. TMP-SMZ is recommended for use in adults and children for urinary tract infections, bronchitis, sinusitis, and otitis media and for prophylaxis against opportunistic infections due to parasites and pneumocystitis jirovecii. TMP-SMZ is available in multiple generic and trade formulations in tablets containing 80 or 160 mg of trimethoprim and 200, 400, or 800 mg of sulfamethoxazole. Trade names include Bactrim, Cotrim, and Septra. TMP-SMZ is usually well tolerated but has many reported adverse side effects including fatigue, weakness, insomnia, dizziness, headache, nausea, diarrhea, and rash. Rare but potential severe adverse events include hypersensitivity reactions, drug rashes, Drug Reaction with Eosinophilia and Systemic Symptoms (DRESS), Stevens-Johnson syndrome, toxic epidermal necrolysis, aplastic anemia, agranulocytosis, thrombocytopenia, anaphylaxis, shock, Clostridioides difficile associated diarrhea, and embryo-fetal toxicity.

Trimethoprim is also available separately and is used as an antibiotic for uncomplicated urinary tract infections. Trimethoprim is a synthetic antifolate that acts on a late step in the pathway of folate synthesis. Trimethoprim has activity against many aerobic gram-negative organisms such as Escherichia coli, Kiebsiella pneumoniae, Proteus mirabilis and Enterobacter species. Resistance is common. Trimethoprim was approved for use in the United States in 1980, but is used much less frequently that TMP-SMZ. Trimethoprim is available in several generic forms in tablets of 100 mg and the usual oral adult dose regimen is 100 mg twice daily for 10 days. Trimethoprim is generally well tolerated; side effects can include nausea, abdominal upset, rash and pruritus.

### Hepatotoxicity

TMP-SMZ is a well-known cause of acute drug-induced liver injury and typically has features suggestive of hypersensitivity much like other sulfonamides. In most recent case series from the United States and Europe, TMP-SMZ ranked among the top 5 causes of drug-induced idiosyncratic liver injury. The estimated incidence of liver injury after TMP-SMZ use ranges from 1 per 2,000 to 1 per 5,000 treated patients. The typical latency to onset is 2 to 8 weeks. Cases with shorter latencies are likely due to re-challenge after minor or forgotten toxicity with the previous exposures. At least half of cases are accompanied by signs and symptoms of hypersensitivity such as fever, rash, facial edema, lymphadenopathy, and peripheral eosinophilia (Case 1). Liver injury can be an accompanying finding in patients with DRESS syndrome, or more rarely, Stevens Johnson syndrome (SJS) or toxic epidermal necrosis (TEN). The most frequent pattern of initial enzyme elevations is mixed, but markedly cholestatic and markedly hepatocellular patterns occur. For unknown reasons, injury in children and young adults is more often hepatocellular, while cholestatic cases occur more frequently in the elderly. The course of the liver injury may be short-lived with rapid recovery or complicated and prolonged. Cases with cholestatic TMP-SMZ related liver injury are often prolonged and some are accompanied by varying degrees of bile duct injury and loss leading to vanishing bile duct syndrome and chronic cholestasis which, if severe, can lead to biliary cirrhosis, chronic liver failure, and death or need for liver transplantation. However, most cases of vanishing bile duct syndrome usually improve spontaneously over time, with gradual resolution of jaundice and symptoms, leaving minor alkaline phosphatase and GGT elevations that may persist for years.

As with other sulfonamides, TMP-SMZ can also cause acute hepatocellular injury that ranges in severity from mild (Case #2) to severe and can lead to acute liver failure and death (Case #3). Hepatocellular injury with jaundice is associated with a high mortality rate, and in large case series, TMP-SMZ ranks within the top 10 causes of drug induced, idiosyncratic fulminant hepatic failure. However, most hepatocellular injury cases resolve rapidly upon stopping the drug, usually within 2 to 4 weeks. TMP-SMZ can also cause mild to moderate elevations in ALT levels without jaundice and symptoms. TMP-SMZ liver injury with prominent symptoms or signs of hypersensitivity may be accompanied by hepatic granulomas on liver biopsy.

Clearly TMP-SMZ related liver injury presents in a wide spectrum of clinical phenotypes. Perhaps most characteristic is the sudden development of fever and rash followed a few days later by jaundice within a few weeks of starting the medication. Latencies longer than 8 weeks are rare even with chronic prophylactic use of TMP-SMZ.

Trimethoprim by itself is also capable of causing idiosyncratic, clinically apparent acute liver injury. The injury usually arises after 2 to 12 weeks of therapy and the typical pattern of serum enzyme elevations is mixed or cholestatic. Immunoallergic features are not common, which separates the typical hepatotoxicity of trimethoprim from that of sulfamethoxazole, the sulfonamide component of TMP-SMZ. In several instances, patients who have developed clinically apparent liver injury due to TMP-SMZ, have re-developed symptoms and laboratory abnormalities when treated with trimethoprim alone. Retreatment of patients after recovery with TMP-SMZ or with another sulfonamide should not be done, as several severe and fulminant cases of recurrence have been described after re-challenge.

Likelihood score: A (well established cause of clinically apparent acute liver injury)

### Mechanism of Injury

The clinical pattern of injury with TMP-SMZ suggests a drug-allergy or hypersensitivity mechanism, perhaps through its metabolism to a toxic, reactive or antigenic metabolite. Adverse hypersensitivity-like reactions to TMP-SMZ are particularly common in HIV-infected individuals, toxicity requiring discontinuation developing in up to 75% of patients, with hepatic enzyme abnormalities in 20%. TMP-SMZ liver injury may be more frequent in persons of African ancestry in whom the HLA-B*35:01 allele appears to be a risk factor. In studies from the United States, African Americans appear to have a higher rate of immunoallergic forms of drug-induced liver injury and are at higher risk for liver injury from sulfonamides, allopurinol, phenytoin, carbamazepine, and lamotrigine than Americans of European ancestry.

### Outcome and Management

TMP-SMZ induced liver injury varies greatly in severity, from mild, anicteric and self-limited liver enzyme elevations, to acute symptomatic hepatitis, to a prolonged cholestatic syndrome, and to acute liver failure. Most cases are self-limited and resolve rapidly with discontinuation of drug, with full recovery within 2 to 8 weeks. Severe cholestatic injury may be prolonged and rare cases of chronic liver injury with vanishing bile duct syndrome have been reported. The hepatic injury may be part of a systemic hypersensitivity reaction and categorized as DRESS syndrome. Rechallenge should not be done, and patients should be told that they are allergic to sulfonamides (“sulfa-drugs”) and not receive other drugs in this class. Trimethoprim by itself can also cause acute liver injury and some patients have re-developed injury when switched from TMP-SMZ to trimethoprim alone. However, in most instances, the sulfonamide component of TMP-SMZ is the culprit. Prednisone has been used with variable success but may be helpful and speed clinical improvement in the allergic features of TMP-SMZ injury (rash, fever, eosinophilia), but has not been shown to ameliorate or shorten the degree of hepatic injury. Corticosteroids do not appear to benefit sulfonamide-induced cholestatic injury without allergic or hypersensitivity manifestations and demonstrate no evidence of benefit for the vanishing bile duct syndrome.

Drug Class: Antiinfective Agents, Sulfonamides

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to TMP-SMZ.(1)

A 47 year old woman was treated with antihistamines and a 7 day course “double strength” trimethoprim-sulfamethoxazole (160 mg/800 mg: TMP-SMZ) for an upper respiratory tract infection. During the final days of treatment, she began to feel unwell and, despite stopping the medication, developed worsening fatigue, nausea and pruritus followed by dark urine, jaundice and right upper quadrant pain. Blood tests showed liver test abnormalities (Table) and she was hospitalized. She had severe itching but no rash or fever. Her liver was tender to palpation, and she was jaundiced. She had no history of liver disease, did not drink alcohol and had no risk factors for viral hepatitis. Her only medications were calcium and multivitamins. She had taken TMP/SMZ at least once in the past and was allergic to penicillin (rash). Tests for hepatitis A, B and C and for autoantibodies were negative. An abdominal ultrasound was normal. Blood counts showed mild eosinophilia. Her jaundice and symptoms rapidly improved and itching and liver test abnormalities resolved within a few weeks.

#### Key Points

Medication: | Trimethoprim (160 mg)-sulfamethoxazole (800 mg)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundiced, hospitalization)
Latency: | One week
Recovery: | Two weeks
Other medications: | Multivitamins, calcium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 days | 0 | 77 | 338 | 7.2 | TMP-SMZ Stopped
9 days | 2 days | 54 | 301
10 days | 3 days | 54 | 281 | 10.2 | Hospitalized
11 days | 4 days | 47 | 261 | 3.4 | Ultrasound normal
12 days | 5 days | 46 | 252 | 2.3
18 days | 11 days | 34 | 151 | 2.4 | Asymptomatic
6 months | 6 months | 14 | 84 | 0.6
Normal Values | | <45 | <130 | <1.2

#### Comment

This patient developed a cholestatic hepatitis with minimal ALT elevations within a week of starting TMP-SMZ. She had a history of taking this medication in the past, but without apparent problems or hypersensitivity reactions. The liver injury was moderately severe but resolved rapidly beginning within 4 days of stopping the medication. Signs of hypersensitivity were mild, but the precipitous onset, peripheral eosinophilia, and rapid recovery fit the pattern of immunoallergic hepatitis due to sulfonamides.

### Case 2. Hypersensitivity reaction and ALT elevations without jaundice attributed to TMP-SMZ.(1)

A 33 year old woman was treated with a 21 day course of trimethoprim-sulfamethoxazole (TMP-SMZ) (80 mg/400 mg) for sinusitis. One day after stopping therapy she developed a macular rash, fever, right upper quadrant abdominal pain and nausea. Three days later she was seen in an emergency room, found to have fever, rash and systemic symptoms, and was hospitalized (Table). She had elevations in ALT and alkaline phosphatase, but serum bilirubin levels remained in the normal range. She had no history of liver disease, high risk behaviors, or exposures to viral hepatitis. She drank little alcohol (1 to 2 drinks per week) and took no other medication except for multivitamins and an occasional ibuprofen. Blood counts were normal except for mild eosinophilia (7%). Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound of the liver was normal without gallstones. Her fever and rash resolved and she was discharged with a diagnosis of sulfonamide hypersensitivity reaction. Liver tests fell into the normal range within 4 weeks on onset of symptoms.

#### Key Points

Medication: | Trimethoprim (80 mg)-sulfamethoxazole (400 mg) (TMP-SMZ)
Pattern: | Hepatocellular (R=14)
Severity: | 1+ (anicteric)
Latency: | Three weeks
Recovery: | Four weeks
Other medications: | Multivitamins, ibuprofen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
25 days | 4 days | 981 | 195 | 0.5 | Hospitalization
26 days | 5 days | 805 | 213 | 0.8 | Normal ultrasound
27 days | 6 days | 623 | 316 | 1.1 | Discharged
5 weeks | 12 days | 156 | 386 | 0.6 | Asymptomatic
6 weeks | 3 weeks | 49 | 168 | 0.4
9 weeks | 5 weeks | 34 | 77 | 0.4
Normal Values | | <45 | <130 | <1.2

#### Comment

This patient had a typical, but mild immunoallergic hepatitis with fever, rash, constitutional symptoms, eosinophilia, and ALT elevations, appearing within 3 weeks of starting TMP-SMZ and resolving rapidly once it was stopped. Despite the height to the ALT elevations, the liver injury was mild, minimally symptomatic, and not associated with jaundice or hepatic synthetic dysfunction. Some degree of ALT or alkaline phosphatase elevations is common in patients who have hypersensitivity reactions to sulfonamides and might be missed if blood testing is not done. This case might also qualify for the diagnosis of DRESS syndrome. The patient should be warned against future exposure to sulfonamides; with second exposures, the liver injury can become more acute and more severe.

### Case 3. Acute liver failure due to TMP-SMZ.(1)

A 49 year old man developed jaundice within days of stopping a one week course of oral trimethoprim-sulfamethoxazole (TMP-SMZ: 160/800 mg twice daily) which was given for a superficial cellulitis. He subsequently developed worsening anorexia, fatigue, dyspepsia, and pruritus with a generalized body rash, but no fever or chills. He had a history of cocaine use, but denied injection drug use or other risk factors for viral hepatitis. He drank alcohol sparingly and had no history of liver disease or drug allergies. His other medications included ranitidine which he had taken for years for gastroesophageal reflux and ibuprofen which he took intermittently for headaches and body pain. Physical examination showed deep jaundice and a macular papular rash over the trunk. Laboratory tests showed marked elevations in serum bilirubin (29.5 mg/dL) and aminotransferase levels (ALT 2229 U/L, AST 2684 U/L), with minimal increase in alkaline phosphatase (188 U/L). Serum albumin was low (2.3 g/dL) and prothrombin time was mildly elevated (INR 1.2). Tests for acute hepatitis A, B and C (including HCV RNA) were negative. Smooth muscle antibody was present in low titer (1:80), but antinuclear antibody was not detected. Abdominal ultrasound revealed a contracted gallbladder, but no evidence of biliary obstruction. Abdominal CT scan showed a small gallstone but no dilatation of the extra- or intra-hepatic bile ducts. Liver biopsy demonstrated submassive necrosis and collapse with prominent inflammation and eosinophils, suggestive of severe drug induced liver injury. He was treated with corticosteroids, but without improvement in his liver tests. Because of deepening jaundice and progressive hepatic failure, he was referred for liver transplantation, but was not accepted as a candidate because of recent drug use. He subsequently developed complications of liver failure and died three months after initial presentation.

#### Key Points

Medication: | Trimethoprim (160 mg)-sulfamethoxazole (800 mg)(TMP-SMZ)
Pattern: | Hepatocellular (R=~34)
Severity: | 5+ (acute liver failure and death)
Latency: | 3-4 weeks
Recovery: | Incomplete
Other medications: | Ranitidine, ibuprofen chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
5 weeks | 3 weeks | 2229 | 188 | 29.5 | Admission
6 weeks | 4 weeks | 2240 | 166 | 28.7 | Imaging tests
7 weeks | 5 weeks | 1164 | 211 | 22.1 | Liver biopsy
8 weeks | 6 weeks | 855 | 297 | 27.9 | INR 1.4
4 months | 3 months | Died of hepatic failure
Normal Values | | <45 | <130 | <1.2

#### Comment

Sulfonamides can cause acute liver failure and are usually listed in the top 10 cases of fatal drug induced liver injury in large case series. Cases of sulfonamide hepatotoxicity presenting with acute liver failure typically have a hepatocellular pattern of serum enzyme elevations with marked increases in serum aminotransferase levels. Corticosteroids are often used, particularly if immunoallergic features (rash, fever, eosinophilia) are present, but it is not clear whether they are beneficial and alter the course and outcome of the liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trimethoprim-Sulfamethoxazole – Generic, Bactrim®, Septra®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sulfamethoxazole+trimethoprim)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Trimethoprim-Sulfamethoxazole | 8064-90-2 | C14-H18-N4-O3. C10-H11-N3-O3-S

## CITED REFERENCES

1 Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575..36848311

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2026

Abbreviations: TMP-SMZ, trimethoprim and sulfamethoxazole; DRESS, drug reaction with eosinophilia and systemic symptoms; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis; iv, intravenous; HLA, human leukocyte antigen.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Expert review of the sulfonamides and sulfones published in 1999; sulfonamides are thought to cause clinically apparent liver injury in 0.5-1.0% of recipients generally with a sudden onset within 14 days of starting, often with immunoallergic features and a hepatocellular or mixed pattern of injury; mortality may be as high as 10%).
Moseley RH. Sulfonamides. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics including sulfonamides).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-1021. (Textbook of pharmacology and therapeutics).
Dujovne CA, Chan CH, Zimmerman HJ. Sulfonamide hepatic injury. Review of the literature and report of a case due to sulfamethoxazole. N Engl J Med 1967; 277: 785-8. [] (Classic description of sulfonamide hepatotoxicity: case report of a 38 year old man who developed jaundice after 14 days of sulfamethoxazole [3rd exposure] with positive rechallenge; review of the literature on over 100 cases: usual latency of 1-4 weeks, shorter on rechallenge, rash and fever common). 6046676
Frisch JM. Clinical experience with adverse reactions to trimethoprim-sulfamethoxazole. J Infect Dis 1973; 128: Suppl: 607-12 p. []4271305 (Review of post-marketing adverse event reporting on TMP-SMZ from 1968-72, 2151 reports, 32 hepatobiliary [1.5%]).
Tönder M, Nordöy A, Elgjo K. Sulfonamide-induced chronic liver disease. Scand J Gastroenterol 1974; 9: 93-6. [] (54 year old woman developed jaundice 4 weeks after starting TMP-SMZ [bilirubin 7.0 mg/dL, ALT 1180, Alk P twice normal], recurring with re-exposure and after 1 day after "provocation test", the injury was not really chronic as all tests were normal in follow up after stopping). 4453809
Colucci CF, Lo Cicero M. Hepatic necrosis and trimethoprim-sulfamethoxazole. JAMA 1975; 233: 952-3. Letter. [] (80 year old man developed jaundice [bilirubin 10 mg/dL, ALT 135 U/L, Alk P 245 U/L] 10 days after a 10 day course of TMP-SMZ progressing to hepatic failure; massive hepatic necrosis on autopsy). 1173911
Brøckner J, Bøisen E. Fatal multisystem toxicity after co-trimoxazole. Lancet 1978; 1: 831. [] (63 year old man had hypersensitivity reaction after 10 days of TMP-SMZ with multiorgan failure; liver component may have been due to shock and sepsis). 85859
Stevenson DK, Christie DL, Haas JE. Hepatic injury in a child caused by Trimethoprim-Sulfamethoxazole. Pediatrics 1978; 61: 864-6. [] (16 year old boy developed rash and fever 7 weeks after starting TMP-SMZ [bilirubin 9.4 mg/dL, ALT 294 U/L, Alk P 880 U/L, 13% eosinophils], no mention of recovery). 673549
Wormser GP, Keusch GT. Trimethoprim-sulfamethoxazole in the United States. Ann Intern Med 1979; 91: 420-9. [] (Review of indications, efficacy and safety of TMP-SMZ). 382938
Nair SS, Kaplan JM, Levine LH, Geraci K. Trimethoprim-sulfamethoxazole-induced intrahepatic cholestasis. Ann Intern Med 1980; 92: 511-2. (61 year old man with cholestatic hepatitis with minimal ALT and Alk P elevations after 10 days of TMP-SMZ, resolving in 2 months). 7362156
Ogilvie AL, Toghill PJ. Cholestatic jaundice due to co-trimoxazole. Postgrad Med J 1980; 56: 202-4. [PMC free article (https://www.ncbi.nlm.nih.gov/pmc/articles/PMC2425863/)] [] (70 year old woman with severe cholestatic hepatitis with vague previous history of exposure to TMP-SMZ and prolonged exacerbation with restarting treatment before full recovery). 7393813
Abi-Mansur P, Ardiaca MC, Allam C, Shamma'a M. Trimethoprim-sulfamethoxazole-induced cholestasis. Am J Gastroenterol 1981; 76: 356-9. [] (52 year old woman developed jaundice within 7 days of starting TMP-SMZ [bilirubin 11.2 mg/dL, ALT 78 U/L, Alk P 210 U/L], recovery within 2 months of stopping). 7325149
Coto H, McGowan WR, Pierce EH Jr, Thomas E. Intrahepatic cholestasis due to trimethoprim-sulfamethoxazole. South Med J 1981; 74: 897-8. [] (55 year old man developed fever and jaundice 1 week after stopping a 2 week course of TMP-SMZ [bilirubin 7.1 mg/dL, AST 86 U/L, Alk P 1341 U/L], resolving within 6 weeks of onset). 7256343
Ransohoff DF, Jacobs G. Terminal hepatic failure following a small dose of sulfamethoxazole-trimethoprim. Gastroenterology 1981; 80: 816-9. [] (70 year old man, with a history of rash after taking TMP-SMZ, developed rash followed by jaundice after 2 doses of TMP/SMZ with progressive acute liver failure [bilirubin 32 rising to 44 mg/dL, AST 2390 U/L, Alk P 270 U/L] and death, autopsy showing massive necrosis). 7202951
Steinbrecher UP, Mishkin S. Sulfamethoxazole-induced hepatic injury. Dig Dis Sci 1981; 26: 756-9. [] (53 year old woman developed fever and arthralgias followed by jaundice 3 days after 10 day course of sulfamethoxazole with mixed enzyme pattern and recovery in ~6 weeks, recurrence with retreatment – twice) 7261840
Jick H. Adverse reactions to trimethoprim-sulfamethoxazole in hospitalized patients. Rev Infect Dis 1982; 4: 426-8. [] (Follow up of 40,000 patients admitted to 25 Boston hospitals from 1966-80, 1,121 received TMP-SMZ, and 91 [8%] had an adverse reaction, usually gastrointestinal upset [3.7%], skin rash [3.3%], fever [0.2%], no reports of liver injury or jaundice). 6981160
Lawson DH, Paice BJ. Adverse reactions to trimethoprim-sulfamethoxazole. Rev Infect Dis 1982; 4: 429-33. PMID: (Review of world’s literature on TMP-SMZ adverse drug reactions; common side effects are gastrointestinal upset and skin rash; liver injury is rare ~2% of reported adverse events). 7051241
Ghishan FK. Trimethoprim-sulfamethoxazole-induced intrahepatic cholestasis. Clin Pediatr (Phila) 1983; 22: 212-4. (5 year old girl developed rash, fever and jaundice one week after starting TMP-SMZ [bilirubin 6.5 mg/dL, ALT 44 U/L, Alk P 776 U/L], recovery within 2 weeks). 6600661
Gordin FM, Simon GL, Wofsy CB, Mills J. Adverse reactions to trimethoprim-sulfamethoxazole in patients with the acquired immunodeficiency syndrome. Ann Intern Med 1984; 100: 495-9. PMID: (Retrospective review of 38 HIV-positive patients treated with TMP-SMZ found 75% rate of dose limiting toxicity, 60% severe, and 20% had serum ALT elevations, starting within 1-2 weeks of starting). 6230976
Horák J, Mertl L, Hrabal P. Severe liver injuries due to sulfamethoxazole-trimethoprim and sulfamethoxydiazine. Hepatogastroenterology 1984; 31: 199-200. (Two case reports, 47 year old woman developed acute liver failure and died with onset of jaundice within 1 week of starting TMP-SMZ; 26 year old man developed prolonged jaundice arising 10 days after starting TMP-SMZ and slow recovery). 6510880
Thies PW, Dull WL. Trimethoprim-sulfamethoxazole-induced cholestatic hepatitis. Inadvertent rechallenge. Arch Intern Med 1984; 144: 1691-2. (54 year old man developed jaundice within 1 week of starting TMP-SMZ [bilirubin 5.0 mg/dL, ALT 255 U/L, GGT 198 U/L], resolving in 4 weeks with positive inadvertent rechallenge with 3 day latency). 6331808
Bartlett JC, Park H, Moe R. Hepatic toxicity associated with trimethoprim-sulfamethoxazole: report of a case. J Am Osteopath Assoc 1985; 85: 381-2. (67 year old developed rash, fever and nausea within 1 week of starting TMP-SMZ, but continued drug for 4 weeks when he was found to be jaundiced with bilirubin 9.8 mg/dL, AST 150 U/L, Alk P 332 U/L). 3877712
Beard K, Belic L, Aselton P, Perera DR, Jick H. Outpatient drug-induced parenchymal liver disease requiring hospitalization. J Clin Pharmacol 1986; 26: 633-7. (Survey of a Health Management Organization admissions over 5 years identified only 12 cases of drug induced liver injury, 1 due to sulfonamides [1:6400 exposures] and one to TMP-SMZ [1:12,706 exposures]). 3793956
Tanner AR. Hepatic cholestasis induced by trimethoprim. Br Med J (Clin Res Ed) 1986; 293: 1072-3. (49 year old woman developed TMP-SMZ induced cholestatic hepatitis with latency of 3 weeks and resolution in 8 weeks, developed similar pattern after five days of TMP alone). 3094778
Berg PA, Daniel PT. Co-trimoxazole-induced hepatic injury--an analysis of cases with hypersensitivity-like reactions. Infection 1987; 15 Suppl 5: S259-64. (Review of hepatotoxicity of TMP-SMZ with detailed descriptions of cases in the literature). 3501774
Oliver RM, Rickenbach MA, Thomas MR, Neville E. Intrahepatic cholestasis associated with co-trimoxazole. Br J Clin Pract 1987; 41: 975-6. (65 year old man developed jaundice 4 weeks after starting TMP-SMZ therapy [bilirubin 4.5 mg/dL, AST 114 U/L, Alk P > 500 U/L], resolving within 3 months of stopping). 3509795
Alberti-Flor JJ, Hernandez ME, Ferrer JP, Howell S, Jeffers L. Fulminant liver failure and pancreatitis associated with the use of sulfamethoxazole-trimethoprim. Am J Gastroenterol 1989; 84: 1577-9. (26 year old man developed acute liver failure and pancreatitis 5 days after starting TMP-SMZ while also taking 4.5 grams of acetaminophen daily, which may have contributed to the liver injury). 2596461
Kumar VV, Mahesh BV, Raju VK, Devi KR. Trimethoprim induced intrahepatic cholestasis. Indian Pediatr 1989; 26: 181-3. (10 year old boy developed jaundice 10 days after starting TMP-SMZ [bilirubin 8.0 mg/dL, AST 80, Alk P 5 times ULN] with rapid resolution; 3 months later a course of TMP alone led to jaundice within 1 week with similar pattern of serum enzyme elevations). 2753538
Muñoz SJ, Martinez-Hernandez A, Maddrey WC. Intrahepatic cholestasis and phospholipidosis associated with the use of trimethoprim-sulfamethoxazole. Hepatology 1990; 12: 342-7. (60 year old woman developed jaundice 4 days after starting TMP-SMZ [bilirubin 20.5 mg/dL, Alk P 502 U/L, AST 188 U/L], not resolving until 6 months after stopping). 2167870
Cockerill FR, Edson RS. Trimethoprim-sulfamethoxazole. Mayo Clin Proc 1991; 66: 1260-9. (Review of pharmacology, efficacy and safety of TMP-SMZ). 1749295
van der Ven AJ, Koopmans PP, Vree TB, van der Meer JW. Adverse reactions to co-trimoxazole in HIV infection. Lancet 1991; 338: 431-3. (Hypothesis paper on the high rates of hypersensitivity to sulfonamides among AIDS patients). 1678095
Kowdley KV, Keeffe EB, Fawaz KA. Prolonged cholestasis due to trimethoprim sulfamethoxazole. Gastroenterology 1992; 102: 2148-50. (Two women, ages 43 and 48 years, developed prolonged cholestasis after exposure to TMP-SMZ with latency to onset of rash of 4 days, but 2-3 weeks to onset of jaundice [bilirubin 3.6 and 27.1 mg/dL, ALT 422 and 63 U/L, Alk P 229 and 306 U/L], requiring 12 and 18 months to recover). 1587437
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; 62 cases [5%] were attributed to either TMP-SMZ or SMZ alone). 1506809
Malnick SD, Atali M, Israeli E, Abend Y, Geltner D. Trimethoprim/sulfamethoxazole-induced rash, fever, abnormal liver function tests, leukopenia, and thrombocytopenia. Ann Pharmacother 1993; 27: 1139-40. (54 year old woman developed rash, fever and cytopenia with minimal ALT elevations 5 days after starting TMP-SMZ). 8219452
Carr A, Tindall B, Penny R, Cooper DA. Patterns of multiple-drug hypersensitivities in HIV-infected patients. AIDS 1993; 7: 1532-3. (Survey of 108 AIDs patients for history of allergic reactions to antibiotics, 39% reported allergy to sulfonamides, often cross reactive, but not always [dapsone vs TMP-SMZ]). 8280426
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119(7 Pt 1): 576-83. (In Medicaid records between 1980-87, 107 patients were hospitalized for acute hepatitis of unknown cause, 8 had received TMP-SMZ, estimated risk from sulfonamides was <1 per 100,000 prescriptions). 8363168
Altraif I, Lilly L, Wanless IR, Heathcote J. Cholestatic liver disease with ductopenia (vanishing bile duct syndrome) after administration of clindamycin and trimethoprim-sulfamethoxazole. Am J Gastroenterol 1994; 89: 1230-4. (Two case reports; 30 year old man developed TMP-SMZ induced allergic hepatitis with jaundice evolving into a prolonged cholestatic syndrome with ductopenia). 8053440
Pickert CB, Belsha CW, Kearns GL. Multi-organ disease secondary to sulfonamide toxicity. Pediatrics 1994; 94: 237-9. (13 year old boy developed rash during 3 week course of TMP-SMZ followed 10 days later by fever and pharyngitis with eosinophilia [25%], AST 252 U/L, GGT 210 U/L and renal failure with slow recovery). 8036081
Lindgren A, Olsson R. Liver reactions from trimethoprim. J Intern Med 1994; 236: 281-4. (Summary of Swedish adverse drug reaction reports of 21 cases of liver injury due to TMP alone; latency 5 to 24 days, all recovered, similar onset as to TMP-SMZ, but no details given). 8077884
Jick H, Derby LE. A large population-based follow-up study of trimethoprim-sulfamethoxazole, trimethoprim, and cephalexin for uncommon serious drug toxicity. Pharmacotherapy 1995; 15: 428-32. (Boston database on 232,390 patients given TMP-SMZ and 266,951 given TMP alone; rates of hepatic events similar with both drugs: 3.8-5.2/100,000 exposed persons). 7479194
Simma B, Meister B, Deutsch J, et al. Fulminant hepatic failure in a child as a potential adverse effect of trimethoprim-sulphamethoxazole. Eur J Pediatr 1995; 154: 530-3. (5 year old given TMP-SMZ and then amoxicillin-clavulanate and two weeks later developed jaundice [bilirubin 20.5 mg/dL, ALT 546 U/L, Alk P 538 U/L], progressing to liver failure and need for emergency transplantation). 7556317
George DK, Crawford DH. Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf 1996; 15: 79-85. (Review of hepatotoxicity from antibiotics including sulfonamides indicating that transient increases in aminotransferase levels occur in 10% of patients, but that clinical liver injury is rare, in one study <1,100,000 prescriptions). 8862966
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; TMP-SMZ accounted for 29 (ranking 9th), 1 case being fatal). 8816722
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Review of studies of drug induced liver injury from the UK general practice database identified 23 cases of liver injury from TMP-SMZ among 232,390 users giving an incidence rate of 3.2 per 100,000 prescriptions, a rate similar to comparable antibiotics). 9250549
Rieder MJ, King SM, Read S. Adverse reactions to trimethoprim-sulfamethoxazole among children with human immunodeficiency virus infection. Pediatr Infect Dis J 1997; 16: 1028-31. (Single center survey; 40% of 25 children with HIV treated with TMP-SMZ developed short latency onset allergic reactions, none hepatic). 9384334
Ilario MJ, Ruiz JE, Axiotis CA. Acute fulminant hepatic failure in a woman treated with phenytoin and trimethoprim-sulfamethoxazole. Arch Pathol Lab Med 2000; 124: 1800-3. (60 year old woman developed acute liver failure while receiving both phenytoin and TMP-SMZ). 11100060
Windecker R, Steffen J, Cascorbi I, Thürmann PA. Co-trimoxazole-induced liver and renal failure. Case report. Eur J Clin Pharmacol 2000; 56: 191-3. (48 year old man developed jaundice [bilirubin 10.2 mg/dL, ALT 723 U/L, Alk P 413 U/L], with bone marrow and renal failure 6 days after 10 day course of TMP-SMZ, ultimately recovering within 6 months). 10877016
Mainra RR, Card SE. Trimethoprim-sulfamethoxazole-associated hepatotoxicity - part of a hypersensitivity syndrome. Can J Clin Pharmacol 2003; 10: 175-8. (24 year old woman developed fever, eosinophilia and jaundice while taking multiple herbal medications and after a brief course of TMP-SMZ [bilirubin 10.0 mg/dL, ALT 2479 U/L, Alk P 472 U/L], severe course but ultimate recovery). 14712321
Zaman F, Ye G, Abreo KD, Latif S, Zibari GB. Successful orthotopic liver transplantation after trimethoprim-sulfamethoxazole associated fulminant liver failure. Clin Transplant 2003; 17: 461-4. (23 year old man developed liver injury arising within 7 days of starting TMP-SMZ [bilirubin rising from 0.8 to 6.9 to 10.3 mg/dL, ALT 1706 U/L], evolving rapidly into acute liver failure and need for transplant). 14703931
Karpman E, Kurzrock EA. Adverse reactions of nitrofurantoin, trimethoprim and sulfamethoxazole in children. J Urol 2004; 172: 448-53. (Review article on side effects of antibiotics used in pediatric urologic practice). 15247700
Slatore CG, Tilles SA. Sulfonamide hypersensitivity. Immunol Allergy Clin North Am 2004; 24: 477-90, vii. PMID: 15242722 (Review of mechanisms of hypersensitivity to sulfonamides).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to sulfasalazine and 1 to TMP-SMZ). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network between 1994-2004, included 461 cases of drug induced liver disease; sulfonamides were not mentioned in the top 19 causes [drugs with 5 or more cases]). 16083708
Garcia Rodriguez LA, Ruigomez A, Jick H. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; 21 drugs were associated with more than 50 cases each, including TMP-SMZ [ranking 10th]). 16054882
Kouklakis G, Mpoumponaris A, Zezos P, Moschos J, Koulaouzidis A, Nakos A, Pehlivanidis A, et al. Cholestatic hepatitis with severe systemic reactions induced by trimethoprim-sulfamethoxazole. Ann Hepatol 2007; 6: 63-5. (30 year old man developed fever and rash 2 weeks after stopping a 15 day course of TMP-SMZ [bilirubin 2.9 mg/dL, ALT 456 U/L, Alk P 223 U/L], resolving within 3 months of onset). 17297432
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 9 were due to TMP-SMZ, which ranked 4th as a cause). 18955056
Crowell CS, Melin-Aldana H, Tan TQ. Fever, rash, and hepatic dysfunction in a 3-year-old child: a case report. Clin Pediatr (Phila) 2008; 47: 517-20. (3 year old boy with rash, fever, cough and 19% atypical lymphocytes was thought to have Kawasaki disease or mononucleosis, but later found to have received TMP-SMZ 1 week before onset [bilirubin 1.6 mg/dL, ALT 354 U/L, Alk P 351 U/L], rapid response to corticosteroids). 18509155
Hanses F, Zierhut S, Schölmerich J, Salzberger B, Wrede CE. Severe and long lasting cholestasis after high-dose co-trimoxazole treatment for Pneumocystis pneumonia in HIV-infected patients-a report of two cases. Int J Infect Dis 2009; 13: e467-9. (Two patients with HIV infection and pneumocystis pneumonia developed elevations in Alk P and bilirubin while on TMP-SMZ, but both also had CMV infection and multiple complications, and abnormalities persisted long term). 19299179
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, TMP-SMZ accounting for 48 cases [0.5%] for an adjusted odds ratio of 1.3). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; dapsone accounted for 17 cases [5.4% of which 2 were fatal, and TMP-SMZ accounted for 7 cases [2.2%], but none were fatal]. 20648003
García-Aparicio J, Herrero-Herrero JI. [Toxic hepatitis following sequential treatment with cotrimoxazol, levofloxacin, doxycycline and sertraline in a patient with a respiratory infection]. Farm Hosp 2010; 34: 152-4. Spanish. PMID: 20471573 (65 year old woman developed jaundice shortly after having received TMP-SMZ as well as doxycycline and levofloxacin for a urinary tract infection [bilirubin 3.5 rising to 14.2 mg/dL, ALT 937 U/L, Alk P 373 U/L], resolving within 3 months of onset).
Bell TL, Foster JN, Townsend ML. Trimethoprim-sulfamethoxazole-induced hepatotoxicity in a pediatric patient. Pharmacotherapy 2010; 30: 539. (9 year old boy developed fever and abdominal pain without rash 14 days after starting a course of TMP-SMZ [bilirubin 0.6 mg/dL, ALT 624 U/L, Alk P 153 U/L, 9% eosinophils], resolving within a week of stopping). 20412003
Chisholm-Burns MA, Patanwala AE, Spivey CA. Aseptic meningitis, hemolytic anemia, hepatitis, and orthostatic hypotension in a patient treated with trimethoprim-sulfamethoxazole. Am J Health Syst Pharm 2010; 67: 123-7. (37 year old man developed fever and rash 8 days after starting TMP-SMZ [bilirubin 2.3 mg/dL, ALT 1290 U/L, Alk P not given], with hemolytic anemia, resolving in 2 weeks). 20065266
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 12 due to sulfonamides [9%], 9 from TMP-SMZ and 3 sulfasalazine). 20949552
Devarbhavi H, Karanth D, Prasanna KS, Adarsh CK, Patil M. Drug-Induced liver injury with hypersensitivity features has a better outcome: a single-center experience of 39 children and adolescents. Hepatology 2011; 54: 1344-50. (Between 1997 and 2010, 450 cases of drug induced liver injury were seen at a single center in India, including 45 cases in children [9%], among whom the most common causes were antituberculosis drugs [n=22, 50% mortality], anticonvulsants [phenytoin 10, carbamazepine 6], and dapsone 4; others included 1 case each due to TMP-SMZ, ciprofloxacin, amoxicillin and Ayuryedic agents). 21735470
Bollaert M, Jeulin H, Waton J, Gastin I, Tréchot P, Rabaud C, Schmutz JL, et al. [Six cases of spring DRESS]. Ann Dermatol Venereol 2012; 139: 15-22. French. PMID: 22225738 (Description of 6 cases of DRESS syndrome arising during a single one month period, all with reactivation of herpes virus infections [EBV, HHV-6, HHV-7 or CMV] and due to different medications, including amoxicillin, allopurinol, carbamazepine, trimethoprim-sulfamethoxazole and multiple antibiotics).
Descamps V. [Drug reaction with eosinophilia and systemic symptoms (DRESS)]. Rev Prat 2012; 62: 1347-52. French. PMID: 23424909 (Review of clinical features of DRESS syndrome in French).
Sembera S, Lammert C, Talwalkar JA, Sanderson SO, Poterucha JJ, Hay JE, Wiesner RH, Gores GJ, Rosen CB, Heimbach JK, Charlton MR. Frequency, clinical presentation, and outcomes of drug-induced liver injury after liver transplantation. Liver Transpl 2012; 18: 803-10. (Among 29 cases of suspected drug induced liver injury occurring in patients after liver transplantation, 11 [38%] were attributed to TMP-SMZ the mostly commonly implicated agent). 22389256
Cangemi DJ, Donovan ST, Johnson MM. 62-year-old man with painless jaundice and hyponatremia. Mayo Clin Proc 2013; 88: e49-53. (62 year old man developed jaundice shortly after 4 day course of TMP-SMZ for cellulitis [bilirubin 25.8 mg/dL, ALT 425 U/L, Alk P 1515 U/L], resolving within 3 months of onset). 23726406
Ng CT, Tan CK, Oh CC, Chang JP. Successful extracorporeal liver dialysis for the treatment of trimethoprim-sulfamethoxazole-induced fulminant hepatic failure. Singapore Med J 2013; 54: e113-6. (17 year old man developed fever and rash 28 days after starting TMP-SMZ for acne [bilirubin 3.0 rising to 19.2 mg/dL, ALT 1660 U/L, Alk P 227 U/L, eosinophils 670/μL], progressing to hepatic failure, but ultimate recovery without liver transplantation within 2 months of onset). 23716163
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 that were attributed to TMP-SMZ). 23419359
Yang JJ, Huang CH, Liu CE, Tang HJ, Yang CJ, Lee YC, Lee KY, Tsai MS, et al. Multicenter study of trimethoprim/sulfamethoxazole-related hepatotoxicity: incidence and associated factors among HIV-infected patients treated for Pneumocystis jirovecii pneumonia. PLoS One 2014; 9: e106141. (Among 284 HIV infected patients treated with SMZ-TMP for P. jirovecii pneumonia, 152 [53%] developed liver test abnormalities which was attributed to SMP/TMP in 47 [17%] of whom 3 [1%] developed jaundice, but none died of liver failure). 25184238
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to dapsone or TMP-SMZ). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases were attributed to TMP-SMZ [3.5%] ranking 4th in frequency). 25754159
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. Idiosyncratic drug induced liver injury in African Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol. 2017;112:1382-1388.. (Among 1182 patients enrolled in a prospective study of drug-induced liver injury in the United States between 2004 and 2016, the most frequently implicated agent among Blacks was TMP-SMZ [7.6%] while it ranked 5^th^ among Whites [3.6%] among whom Amoxicillin-Clavulanate was most frequently implicated [13.4%] which ranked 4^th^ among Blacks [4.1%]. 28762375
Slim R, Asmar N, Yaghi C, Honein K, Sayegh R, Chelala D. Trimethoprim-sulfamethoxazole-induced hepatotoxicity in a renal transplant patient. Indian J Nephrol. 2017;27:482-483.. (38 year old Indian male underwent renal transplantation and was started on TMP/SMZ for prophylaxis against Pneumocystis pneumonia and was found to have abnormal liver tests without symptoms or jaundice 9 days later [bilirubin normal, ALT 375 U/L, GGT 571 U/L] which resolved rapidly resolved once TMP/SMZ was stopped]. 29217891
Kathi PR, Tama M, Ehrinpreis M, Mutchnick M, Westerhoff M, Mowers J, Fontana RJ. Vanishing bile duct syndrome arising in a patient with HIV infection sequentially treated with trimethoprim/sulfamethoxazole and dapsone. Clin J Gastroenterol. 2020;13:276-280.. (58 year old African American man with HIV infection developed pruritus within 2 days and jaundice by 8 days of starting TMP-SMZ [bilirubin 11.9 mg/dL, ALT 1519 U/L, Alk P 1345 U/L] which resolved slowly after stopping but recurred 9 months later within 7 days of starting dapsone [bilirubin 16.9 mg/dL, ALT 282 U/L, Alk P 1353 U/L] which did not improve upon stopping, resulting in persistent jaundice, intractable pruritus, and liver biopsy showing vanishing bile duct syndrome resulting in hepatic failure and death 2 years later). 31317370
Siddique AS, Siddique O, Einstein M, Urtasun-Sotil E, Ligato S. Drug and herbal/dietary supplements-induced liver injury: A tertiary care center experience. World J Hepatol. 2020;12:207-219.. (Among 38 patients with suspected drug induced liver injury who presented at a single US referral center between 2013 and 2017, one was attributed to TMP-SMZ [bilirubin 10.9 mg/dL, ALT 152 U/L, Alk P 198 U/L] with macrovesicular steatosis and cholestasis on liver biopsy). 32547688
Sharma B, Antoine M, Shah M, John S. Idiosyncratic drug-induced liver injury secondary to trimethoprim-sulfamethoxazole. Am J Ther. 2020;27:e664-e667.. (44 year old woman developed nausea and abdominal pain 4 days after starting TMP-SMZ for a urinary tract infection, with rash and fever [bilirubin 0.8 rising to 2.2 mg/dL, ALT 563 rising to 6916 U/L, Alk P 100 rising to 164 U/L] with improvement on stopping TMP/SMZ and administration of N-acetyl cysteine). 31425162
Li YJ, Phillips EJ, Dellinger A, Nicoletti P, Schutte R, Li D, Ostrov DA, et al; Drug-induced Liver Injury Network. Human Leukocyte Antigen B*14:01 and B*35:01 are associated with trimethoprim-sulfamethoxazole induced liver injury. Hepatology. 2021;73:268-281.. (Among 71 patients with liver injury attributed to use of TMP-SMZ, HLA testing showed an association with HLA-B*14:01 found among 5 of 51 European Americans (AF 0.049 vs 0.009) but not African Americans among whom 5 of 10 had B*35:01 [AF 0.25 vs 0.09]) 32270503
van Asperdt JAA, De Moor RA. Aseptic meningitis, hepatitis and cholestasis induced by trimethoprim/sulfamethoxazole: a case report. BMC Pediatr. 2021;21:345.. (2.5 year old girl was hospitalized for meningitis 2 weeks after starting TMP-SMZ for otitis and developed jaundice 4 days later [bilirubin 4.4 rising to 5.8 mg/dL, ALT 358 U/L, GGT ~450 U/L] with clinical resolution and near normal values 34 days after stopping). 34399711
Huang YS, Tseng SY, Chang TE, Perng CL, Huang YH. Sulfamethoxazole-trimethoprim-induced liver injury and genetic polymorphisms of NAT2 and CYP2C9 in Taiwan. Pharmacogenet Genomics. 2021;31:200-206.. (Among 158 Han Chinese patients seen at Taipei Veterans General Hospital between 2003 and 2010 with suspected TMP-SMZ hepatotoxicity, slow NAT2 acetylation status was more frequent in patients than in 145 controls who tolerated therapy [42% vs 26%], with no clear association with age, latency, or clinical features. 34149005
Hindosh N, Kotala R, Nguyen K, Pintor A. Trimethoprim-sulfamethoxazole-induced drug reaction with eosinophilia and systemic symptoms (DRESS) complicated by acute liver failure. Cureus. 2022;14:e30852.. (57 year old Asian American man developed fatigue, fever, and rash 2 weeks after finishing of a 2 week course of TMP-SMZ [bilirubin 20.5 mg/dL, ALT 376 U/L, Alk P 1476 U/L, INR 1.2, eosinophils 29%, and platelet count of 1,000/μL], improving after intravenous methylprednisolone but with slow recovery] 36457619
Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575.. (Among 93 cases of TMP- SMZ induced liver injury enrolled in a prospective U.S. database between 2004 and 2020, the median age was 46 years, 52% were female, 76% white and 17% black, 82% were jaundiced with mean bilirubin of 4.3 mg/dL, ALT of 388 U/L, and Alk P of 258 U/L], 40% were severe and 4% fatal or transplanted within 6 months; the proportion of patients with cholestatic injury increased with age while the proportion with hepatocellular injury decreased; a weak association with HLA-B*14:01 was found in Whites (carrier rate 16%] and with HLA-B*35:01 in Blacks). 36848311
Sircar S, Rayan M, Okonoboh P. TMP-SMX induced type 4 hypersensitivity with multi-organ involvement. ID Cases. 2023;34:e01917.. (61 year old man developed fever, rash, and confusion 2 weeks after stopping a one-week course of TMP-SMZ [bilirubin 0.6 mg/dL, ALT 79 rising to 214 U/L, Alk P not given, INR 1.1, creatinine 2.8 mg/dL, platelets 13,000/μL] responding to supportive care and blood test results improving on discharge 5 days later). 37954169
Kato H, Hagihara M, Asai N, Mikamo H, Iwamoto T. Evaluation of effectiveness, hyperkalaemia, and hepatotoxicity of trimethoprim-sulphamethoxazole prophylaxis for Pneumocystis jirovecii pneumonia in paediatric patients: A single-centre retrospective study. Int J Antimicrob Agents. 2024;63:107151.. (Among 215 children with HIV infection seen at a single Japanese referral center between 2018 and 2023, who were given prophylaxis against Pneumocystis jirovecii pneumonia with TMP-SMZ, no child developed pneumocystis pneumonia but 34 [16%] developed hepatotoxicity, but no information given about severity, jaundice, hospitalizations, or outcomes). 38508538
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including 32 attributed to SMZ for an estimated incidence rate of 1 per 1960 patients exposed). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, only 3 were attributed to TMP-SMZ, 3 to sulfadiazine, 2 to dapsone, and one to sulfasalazine). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 75 cases [6%] attributed to TMP-SMZ making it the second most frequently implicated drug, occurring at a rate estimated at 1 per 4,900 persons treated).
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1. 39447947. (Analysis of a health database of 16 Indiana University Health hospitals between 2017 and 2022, identified 54 cases of drug-induced liver injury to commonly implicated agents such as azithromycin [15 cases], amoxicillin-clavulanate [8], levofloxacin [7], and ciprofloxacin [6); but none were attributed to TMP-SMZ, despite 10,161 persons exposed).
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 2292 patients treated with the 14 most used antibiotics while hospitalized in a single Icelandic referral center between 2012-2023, 52 developed evidence of drug-induced liver injury including 3 attributed to TMP/SMZ for an estimated rate of one per 1096 patients exposed). 40072769
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, Chalasani N; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and high-risk factors. Am J Gastroenterol. 2025 Jun 12:10. Epub ahead of print.. (Among 2121 patients with suspected drug-induced liver injury enrolled in a prospective US registry between 2004 and 2023, 105 were attributed to TMP-SMZ including 20 [19%] with drug-reaction with eosinophilia and systemic symptoms [DRESS] and another 23 [22%] with rash without DRESS). 40504263
Hishinuma M, Hasegawa M, Minatoguchi S, Umeda R, Koide S, Hayashi H, Yuzawa Y, et al. A case of vanishing bile duct syndrome caused by a treatment regimen including avacopan for microscopic polyangiitis. Intern Med. 2025 Sep 11. Epub ahead of print.. (81 year old man with vasculitis developed jaundice 42 days after starting rituximab, prednisolone, avacopan, and prophylaxis with TMP-SMZ [bilirubin 3.1 rising to 35 mg/dL, ALT 274 U/L, Alk P 402 U/L] with progressive cholestasis and liver biopsy showing vanishing bile duct syndrome, which was attributed to avacopan and which led to liver failure and death within 3 months of onset). Bannoud M, Hong L, Ibelaidene M, Acosta M, Mehdizadeh C. Acute liver injury with cholestatic pattern: an adverse effect of trimethoprim-sulfamethoxazole. Cureus. 2025;17:e92749. PMID: 41122585. (52 year old woman developed jaundice 12 days after starting an 11-day course of TMP-SMZ, metronidazole, and phenazopyridine [bilirubin 7.8 mg/dL, ALT 123 U/L, Alk P 903 U/L] with rapid and spontaneous recovery upon stopping). 40930823

## OTHER REFERENCE LINKS

1. Recent References on Trimethoprim-Sulfamethoxazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=bactrim/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Trimethoprim-Sulfamethoxazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=bactrim)